# REGN-EB3 – Atoltivimab, Maftivimab, Odesivimab

Short Chapter

[Preliminary review chapter based on the FDA Product Labeling and Integrated Review only.]

## OVERVIEW

### Introduction

Atoltivimab, maftivimab, and odesivimab are three human monoclonal antibodies to Zaire ebolavirus that are given in combination and used to treat children and adults with acute Zaire ebolavirus infection. Therapy with atoltivimab, maftivimab, and odesivimab has not been associated with serum aminotransferase elevations nor to instances of clinically apparent liver injury.

### Background

Atoltivimab, maftivimab, and odesivimab are three human monoclonal antibodies to the surface glycoprotein of Zaire ebolavirus that are co-formulated and used in combination to treat adults and children with acute ebolavirus infection. Ebolaviruses are single stranded RNA viruses that have caused multiple outbreaks of severe hemorrhagic fever in Western and Equatorial Africa. Ebolavirus is highly infectious and rapidly progressive. The incubation period ranges from 2 to 21 days and the disease presents with fever, muscle aches, and fatigue followed by diarrhea, vomiting, and abdominal pain. In severe cases, these symptoms are followed by coagulopathy, diffuse bleeding, circulatory collapse, and multiorgan failure. The fatality rate in most outbreaks has averaged 50% but is lower with aggressive supportive therapy. Monoclonal antibodies are the only approved antiviral therapy for ebolavirus infections. The antibodies bind to the major surface glycoprotein of the virus inducing immunologic clearance. All three monoclonal antibodies were found to reduce viral loads and improve survival in rhesus macaques with acute, experimental ebolavirus infection. The combination was used in human studies to avoid development of antiviral resistance and was shown to improve survival in children and adults with ebolavirus infection occurring during an outbreak in the Democratic Republic of the Congo. The combination of the three monoclonal antibodies is referred to as REGN-EB3 and by the proprietary name Inmazeb. REGN-EB3 was given accelerated approval by the FDA under Orphan Drug and Breakthrough Therapy designation in 2020. REGN-EB3 is available in single dose vials of 241.7 mg of atoltivimab, maftivimab, and odesivimab in 14.5 mL (16.67 mg of each per mL); and are available in single dose vials of 483.3 mg of each monoclonal antibody in 14.5 mL (33.33 mg of each per mL). The recommended dose regimen is 50 mg/kg of each as a single intravenous infusion. Common adverse events include infusion reactions, fever, chills, tachycardia, tachypnea, nausea, and vomiting. Serious adverse events include severe hypersensitivity reactions including anaphylaxis.

### Hepatotoxicity

Liver injury is frequent in patients with acute ebolavirus infections but there is no evidence that treatment with REGN-EB3 exacerbates the injury. In healthy volunteers, a single intravenous administration of the three monoclonal antibodies did not cause serum aminotransferase or bilirubin elevations. The controlled clinical trial of REGN-EB3 was conducted in the Democratic Republic of Congo in 2018, and adverse events were largely the typical signs and symptoms of acute ebolavirus infection. In the clinical trial conducted in 322 adults and children, serum ALT elevations above 5 times the upper limit of normal (ULN) arose in 10% of REGN-EB3 recipients and 14% of monoclonal antibody control recipients. Since approval of the combination monoclonal antibody therapy in 2020, there have been no reports of clinically apparent liver injury attributed to their use. Prospective, open-label studies of REGN-EB3 in patients with ebolavirus infection continue to be monitored for safety and efficacy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Monoclonal antibodies are degraded by many tissues and metabolized to peptides and amino acids. The antiviral therapy is given as a single infusion. It is unlikely that the monoclonal antibodies could cause either direct or idiosyncratic liver injury. While hypersensitivity reactions to REGN-EB3 might be accompanied by mild elevations in serum enzymes, no such events have been reported.

Drug Class: Monoclonal Antibodies, Ebolavirus Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Atoltivimab, Maftivimab, Odesivimab – Inmazeb®

DRUG CLASS

Monoclonal Antibodies

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Inmazeb)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Atoltivimab | 1299440-37-1 (https://pubchem.ncbi.nlm.nih.gov/substance/381126899) | Monoclonal Antibody | Not Available

## SELECTED BIBLIOGRAPHY

References updated: 14 June 2024

Abbreviations: ULN, upper limit of the normal range.

[Short Chapter information is based largely on FDA Product Labeling and the FDA Integrated Review accessible from the FDA website https://www.accessdata.fda.gov/scripts/cder/daf/index.cfm. All other references have not been fully reviewed and annotated.]

FDA. Integrated Review. 2020. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/761169Orig1s000MultidisciplineR.pdf (FDA summary data on the safety and efficacy of the combination of atoltivimab, maftivimab, and odesivimab [REGN-EB3], submitted in support of the application for approval as therapy of Zaire ebolavirus infection, mentions that ALT elevations arose in 31.8% of 154 patients receiving REGN-EB3 vs 31.0% of 168 receiving a control monoclonal antibody, while ALT values above 5 times ULN arose in 10.4% vs 14.3%).
Sivapalasingam S, Kamal M, Slim R, Hosain R, Shao W, Stoltz R, Yen J, et al. Safety, pharmacokinetics, and immunogenicity of a co-formulated cocktail of three human monoclonal antibodies targeting Ebola virus glycoprotein in healthy adults: a randomised, first-in-human phase 1 study. Lancet Infect Dis. 2018;18:884-893.29929783
Mulangu S, Dodd LE, Davey RT Jr, Tshiani Mbaya O, Proschan M, Mukadi D, Lusakibanza Manzo M, et al.; PALM Consortium Study Team. A randomized, controlled trial of Ebola virus disease therapeutics. N Engl J Med. 2019;381:2293-2303.31774950
Shears P, Garavan C. The 2018/19 Ebola epidemic the Democratic Republic of the Congo (DRC): epidemiology, outbreak control, and conflict. Infect Prev Pract. 2020;2:100038.34368690
Markham A. REGN-EB3: first approval. Drugs. 2021;81:175-178.33432551

## OTHER REFERENCE LINKS

1. Recent References on REGN-EB3: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=REGN-EB3+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on REGN-EB3: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=REGN-EB3)